# Venlafaxine, Desvenlafaxine

## OVERVIEW

### Introduction

Venlafaxine is a serotonin and norepinephrine reuptake inhibitor widely used as an antidepressant. Venlafaxine therapy can be associated with transient asymptomatic elevations in serum aminotransferase levels and has been linked to rare instances of clinically apparent acute liver injury.

### Background

Venlafaxine (ven" la fax' een) is a both a serotonin and norepinephrine reuptake inhibitor that acts by blocking the reuptake of these neurotransmitters in CNS synaptic clefts, thus increasing active levels in the brain which is associated with an antidepressant effect. Venlafaxine was approved for use in the United States in 1995 and is still widely used with more than 16 million prescriptions filled yearly. Current indications include major depressive disorder, generalized and social anxiety disorder, panic disorder and bipolar mood disorder. Venlafaxine is available as tablets of 25, 37.5, 50, 75, 100 and 150 mg and as extended release capsules of 37.5, 75 and 150 mg in multiple generic forms and under the brand name of Effexor. The recommended dosage in adults is 75 mg daily in two or three divided doses, increasing based on tolerance and effects to a maximum of 225 mg daily. Common side effects are drowsiness, dyspepsia, nausea, headache, increased sweating, increased appetite, weight gain and sexual dysfunction. Uncommon but potentially severe adverse events include suicidal thoughts and behaviors, serotonin syndrome, activation of mania, hypertension, abnormal bleedings and angle-closure glaucoma.

Desvenlafaxine (des” ven la fax' een) is the major active metabolite of venlafaxine and has been marketed separately as a serotonin and norepinephrine reuptake inhibitor. Desvenlafaxine is believed to act by blocking the reuptake of neurotransmitters in CNS synaptic clefts, thus increasing active levels in the brain which is associated with an antidepressant effect. Desvenlafaxine was approved for use in the United States in 2008 and is still used with more than 1 million prescriptions filled yearly. Current indications are limited to major depressive disorder. There is little evidence to suggest that it is more effective or has a different spectrum or rate of adverse events as venlafaxine. Desvenlafaxine is available as extended release tablets of 25, 50, or 100 mg in generic forms and under the brand name of Pristiq. The recommended dosage in adults is 50 mg once daily; increasing the dose has not been shown to improve efficacy. While believed to be better tolerated than venlafaxine, desvenlafaxine appears to have a similar spectrum and frequency of side effects.

### Hepatotoxicity

Liver test abnormalities have been reported to occur in less than 1% of patients on venlafaxine or desvenlafaxine, and elevations are usually modest and usually do not require dose modification or discontinuation. Rare instances of acute, clinically apparent episodes of liver injury with marked liver enzyme elevations with or without jaundice have been reported in patients on both venlafaxine but not desvenlafaxine, perhaps because of less overall use of the more recently approved agent. The onset of injury is usually within 1 to 3 months. The patterns of serum enzyme elevation have varied from cholestatic to hepatocellular. All cases have been self-limiting and resolved within a few months. Autoimmune (autoantibodies) and immunoallergic features (rash, fever, eosinophilia) are uncommon or mild. The estimated frequency is 1 per 5000 patients years of exposure.

Likelihood score (venlafaxine): B (highly likely rare causes of clinically apparent liver injury).

Likelihood score (desvenlafaxine): E* (suspected but unproven cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which venlafaxine and desvenlafaxine cause liver injury is not known. Venlafaxine and desvenlafaxine are metabolized by the liver, mainly via the cytochrome P450 system (predominantly CYP 2D6), and hepatotoxicity may be mediated by toxic intermediates of their metabolism. Both agents can also result in significant drug-drug interactions.

### Outcome and Management

The serum aminotransferase elevations that occur on venlafaxine and desvenlafaxine therapy are usually self-limited and do not require dose modification or discontinuation of therapy. Cases of acute and prolonged or severe liver injury have been reported in patients receiving venlafaxine, but there have been no convincing instances of acute liver failure due to venlafaxine or desvenlafaxine therapy in the published literature. Persons with intolerance to venlafaxine or desvenlafaxine may have similar reactions to each other as well as other SSRIs and careful monitoring is warranted if other such agents are used.

Drug Class: Antidepressant Agents

Other Drugs in the Subclass, SNRIs/SSRIs: Citalopram, Escitalopram, Duloxetine, Fluoxetine, Fluvoxamine, Levomilnacipran, Paroxetine, Sertraline, Vilazodone, Vortioxetine

## CASE REPORT

### Case 1. Acute hepatitis with jaundice due to venlafaxine.(1)

A 39 year old woman developed nausea, vomiting, pruritus and jaundice having been on oral therapy with venlafaxine for depression for two and half years, but also having recently increased the dose (from 75 to 300 mg daily) 2 months previously. She had had a cholecystectomy 20 years previously, but had no history of chronic liver disease, alcohol use, or exposures to hepatitis. She was mildly jaundiced and laboratory findings showed a serum bilirubin of 2.6 mg/dL, ALT 2063 U/L, and alkaline phosphatase 274 U/L. Tests for hepatitis A, B, C and E were negative, as were tests for HIV, cytomegalovirus and Epstein Barr virus infections. Autoantibodies were not present, and abdominal ultrasound showed no evidence of biliary obstruction. A liver biopsy showed a cholestatic hepatitis compatible with drug-induced liver injury. Of interest, three years previously she had a similar episode of acute liver injury with jaundice that arose 3 to 4 months after increasing her dose of venlafaxine from 75 to 150 mg daily, having been on this agent for 6 years. Upon stopping venlafaxine after the second episode, she improved minimally and serum bilirubin levels rose to 11.2 mg/dL. She was started on a course of methylprednisolone for 7 days which resulted in a prompt and lasting improvement in liver tests.

#### Key Points

Medication: | Venlafaxine (300 mg daily)
Pattern: | Hepatocellular (R=25)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 2.5 years, 2 months after dose increase
Recovery: | Unclear
Other medications: | None mentioned

#### Comment

In this case, the pattern of serum enzyme elevations was hepatocellular, but symptoms and liver biopsy findings suggested a cholestatic hepatitis. Striking in the history was a previous episode arising years after starting venlafaxine but only a few months after an increase in the daily dose. The long latency to onset of an acute hepatitis is unusual, but a history of a change in drug dose or source of the medication is sometimes given. Cases such as this suggest that idiosyncratic acute liver injury is not completely independent of drug dose.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Venlafaxine – Generic, Effexor®

Desvenlafaxine – Generic, Pristiq®

DRUG CLASS

Antidepressant Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Venlafaxine) (Venlafaxine)

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=VENLAFAXINE) (Desvenlafaxine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Venlafaxine | 93413-69-5 | C17-H27-N-O2
Desvenlafaxine | 93413-62-8 | C16-H25-N-O2

## CITED REFERENCE

1 Stadlmann S, Portmann S, Tschopp S, Terracciano LM. (2012). Venlafaxine-induced cholestatic hepatitis: case report and review of literature. Am J Surg Pathol.

## ANNOTATED BIBLIOGRAPHY

References updated: 06 March 2020

Zimmerman HJ. Antidepressants. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 493-8. (Expert review of hepatotoxicity published in 1999; venlafaxine is not mentioned).
Larrey D, Ripault MP. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 443-62. (Review of hepatotoxicity of antidepressants mentions that clinically apparent liver injury from the SNRIs is rare, venlafaxine having been implicated in occasional cases of cholestatic injury).
O'Donnell JM, Bies RR, Shelton RC. Drug therapy of depression and anxiety disorders. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 267-78. (Textbook of pharmacology and therapeutics).
Schweizer E, Thielen RJ, Frazer A. (1997). Venlafaxine: a novel antidepressant compound. Expert Opin Investig Drugs. (Review of the structure, pharmacology, mechanism of action, efficacy and side effects of venlafaxine; no mention of hepatotoxicity or ALT elevations).
Mourilhe P, Stokes PE. (1998). Risks and benefits of selective serotonin reuptake inhibitors in the treatment of depression. Drug Saf. (Review of pharmacology, efficacy and safety of SSRIs; no mention of ALT elevations or hepatotoxicity).
Kim KY, Hwang W, Narendran R. (1999). Acute liver damage possibly related to sertraline and venlafaxine ingestion. Ann Pharmacother. (27 year old man took overdose of sertraline and cephalexin and had elevations of ALT to 1247 U/L, bilirubin 2.1 mg/dL; switched to venlafaxine but 1 week later developed abdominal pain [bilirubin 1.6 mg/dL, ALT 814 U/L], improving on stopping but relapsing 3 days after restarting sertraline; recovered fully on stopping all SSRIs).
Grohmann R, Rüther E, Engel RR, Hippius H. (1999). Assessment of adverse drug reactions in psychiatric inpatients with the AMSP drug safety program: methods and first results for tricyclic antidepressants and SSRI. Pharmacopsychiatry. (Analysis of reporting of adverse events among inpatients in 29 German hospitals between 1993 to 1997; 896 severe adverse events among 48,564 patients [1.8%], both total and hepatic events were more common with tricyclics than SSRIs).
Horsmans Y, De Clercq M, Sernpoux C. (1999). Venlafaxine-associated hepatitis. Ann Intern Med. (44 year old woman developed fatigue 6 months after starting venlafaxine [ALT 1082 U/L], improving over 6 months after stopping venlafaxine while continuing trazodone; no mention of bilirubin or Alk P levels).
Cardona X, Avila A, Castellanos P. (2000). Venlafaxine-associated hepatitis. Ann Intern Med. (78 year old man developed jaundice 6 weeks after starting venlafaxine [bilirubin 5.1 mg/dL, ALT 238 U/L, Alk P 680 U/L], resolving within 5 weeks of stopping).
Carvajal García-Pando A, García del Pozo J, Sánchez AS, Velasco MA, Rueda de Castro AM, Lucena MI. (2002). Hepatotoxicity associated with the new antidepressants. J Clin Psychiatry. (Analysis of cases of hepatotoxicity from antidepressants in Spanish Pharmacovigilance System from 1989-1999, identified 99 cases; among SSRIs, 26 due to fluoxetine, 14 paroxetine, 6 fluvoxamine, 5 sertraline, 3 venlafaxine and 2 citalopram; among tricyclics, 16 clomipramine 7 amitriptyline, 6 imipramine; among miscellaneous, 3 nefazodone and 1 trazodone; but all similar in rate ~1-3 per 100,000 patient-years of exposure, except for nefazodone=29/100,000).
Maroy B. (2002). Hepatite aigue cytolytique apres de venlafaxine. Gastroenterol Clin Biol. (51 year old man developed jaundice 2 months after starting venlafaxine with mild rash [bilirubin 5.8 mg/dL, ALT 73 times ULN, Alk P 2 times ULN], resolving within 2 months of stopping).
Lucena M, Carvajal A, Andrade R, Velasco A. (2003). Antidepressant-induced hepatotoxicity. Expert Opin Drug Saf. (Review of hepatotoxicity of antidepressants; antidepressant use has increased markedly between 1992 and 2002, accounting for 5% of cases of hepatotoxicity; SSRIs are less likely to cause injury than tricyclics and MAO inhibitors but SSRI liver injury has a range of presentations, although typically self-limited and with rapid recovery and without hallmarks of hypersensitivity).
Spigset O, Hägg S, Bate A. (2003). Hepatic injury and pancreatitis during treatment with serotonin reuptake inhibitors: data from the World Health Organization (WHO) database of adverse drug reactions. Int Clin Psychopharmacol. (Among 27,542 reports of hepatic injury in WHO database, 786 were related to SSRIs [3%], including citalopram 42, fluoxetine 222, fluvoxamine 54, paroxetine 191, sertraline 112, nefazodone 91 and venlafaxine 74; only nefazodone has an excess of hepatic reports in relationship to total reports).
Sencan I, Sahin I, Ozcetin A. (2004). Low-dose venlafaxine-associated liver toxicity in chronic hepatitis. Ann Pharmacother. (30 year old woman with chronic hepatitis B developed ALT elevations [689 U/L] without jaundice 2 months after stopping interferon and 6 weeks after starting venlafaxine, resolving in 6 weeks; unclear whether hepatotoxicity or posttreatment flare of hepatitis B).
Degner D, Grohmann R, Kropp S, Rüther E, Bender S, Engel RR, Schmidt LG. (2004). Severe adverse drug reactions of antidepressants: results of the German multicenter drug surveillance program AMSP. Pharmacopsychiatry. (Analysis of adverse drug reactions reported from 1993-2000 in 35 psychiatric hospitals; 0.7% of SSRI recipients had a severe adverse event; hepatic in 0.05%).
Pinzani V, Peyriere H, Hillaire-Buys D, Pageaux GP, Blayac BP, Larrey D. (2006). Specific serotonin recapture inhibitor (SSRI) antidepressants: hepatoxicity assessment in a large cohort in France. J Hepatol. (Abstract; Analysis of French Pharmacovigilance data on SSRIs found 63 cases of hepatotoxicity from paroxetine, 45 fluoxetine, 30 citalopram, 18 sertraline, and 2 fluvoxamine).
Phillips BB, Digmann RR, Beck MG. (2006). Hepatitis associated with low-dose venlafaxine for postmenopausal vasomotor symptoms. Ann Pharmacother. (60 year old woman developed abdominal pain 1 month after starting venlafaxine [bilirubin normal, ALT 372 U/L, Alk P 758 U/L], with rapid resolution upon stopping and relapse within 6 days of restarting).
Christensen RC, Garces LK. (2006). Hepatotoxic effects with high-dose venlafaxine. Psychiatry (Edgmont). (33 year old man with bipolar disorder developed fatigue and abnormal liver tests 6 months after increasing his daily venlafaxine dose from 150 to 225 mg daily [ALT 188 U/L, bilirubin and Alk P not given], which fell to normal within 2 weeks of reducing the dose back to 150 mg daily).
Sabaté M, Ibáñez L, Pérez E, Vidal X, Buti M, Xiol X, Mas A, et al. (2007). Risk of acute liver injury associated with the use of drugs: a multicentre population survey. Aliment Pharmacol Ther. (Among 126 cases of drug induced liver injury seen in Spain between 1993-2000, 3 were attributed to paroxetine and 3 to fluoxetine, with a relative risk of injury to rate of use in the population of 3.0 and 1.8 respectively).
DeSanty KP, Amabile CM. (2007). Antidepressant-induced liver injury. Ann Pharmacother. (Review of drug induced liver injury and reports of injury from MAO inhibitors, SSRIs, tricyclics and atypical agents).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, 6 were attributed to duloxetine, 3 to atomoxetine, 2 to fluoxetine, 2 to bupropion, and 1 to sertraline as single agents; venlafaxine not mentioned).
Yildirim B, Tuncer C, Ergun M, Unal S. (2009). Venlafaxine-induced hepatotoxicity in a patient with ulcerative colitis. Ann Hepatol. (55 year old man with ulcerative colitis developed fatigue and abdominal pain 2 months after starting venlafaxine [bilirubin normal, ALT 192 U/L, Alk P 419 rising to 696 U/L], resolving within 2 months of stopping).
Detry O, Delwaide J, De Roover A, Hans MF, Delbouille MH, Monard J, Honore P. (2009). Fulminant hepatic failure induced by venlafaxine and trazodone therapy: a case report. Transplant Proc. (48 year old woman developed jaundice and liver failure 4 months after starting venlafaxine and trazodone [bilirubin 30 mg/dL, ALT 990 U/L, INR 4.6], undergoing liver transplantation 3 days after admission).
Arroyo VC, Hallal H, Agudo JL, Aniorte JP. (2009). Gastroenterol Hepatol. (39 year old man developed abdominal pain 10 days after starting venlafaxine [bilirubin rising to 18.6 mg/dL, ALT 103 U/L, Alk P 880 U/L], resolving within 5 months of stopping).
Tourian KA, Padmanabhan SK, Groark J, Brisard C, Farrington D. (2009). Desvenlafaxine 50 and 100 mg/d in the treatment of major depressive disorder: an 8-week, phase III, multicenter, randomized, double-blind, placebo-controlled, parallel-group trial and a post hoc pooled analysis of three studies. Clin Ther. (Among 615 adults with major depression treated with desvenlafaxine [50 or 100 mg], duloxetine [60 mg] or placebo once daily for 8 weeks, there were minimal changes in mean levels of ALT and AST during treatment and significant isolated elevations of ALT or AST occurred in only 2 patients on desvenlafaxine, 1 on duloxetine and 2 on placebo).
Clayton AH, Kornstein SG, Rosas G, Guico-Pabia C, Tourian KA. (2009). An integrated analysis of the safety and tolerability of desvenlafaxine compared with placebo in the treatment of major depressive disorder. CNS Spectr. (Analysis of safety from 9 placebo controlled trials of desvenlafaxine [50 to 400 mg daily] for major depression found that discontinuation due to adverse events was dose related, but rates were similar for the recommended 50 of 50 mg daily to placebo [4.1% vs 3.9%], and that the proportion with “clinically important” changes in liver enzymes were similar between venlafaxine and placebo [1% vs 2%] and there were no serious hepatic adverse events).
Perry R, Cassagnol M. (2009). Desvenlafaxine: a new serotonin-norepinephrine reuptake inhibitor for the treatment of adults with major depressive disorder. Clin Ther. (Systematic review of 8 controlled trials of desvenlafaxine for major depression found efficacy with 50 mg daily and no additional effect with higher doses, while adverse events included nausea, suicidal ideation, weight change and increase in blood pressure; no mention of ALT levels or hepatotoxicity).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, including 1 due to venlafaxine and 1 to fluoxetine but none to other SSRIs).
Molleston JP, Fontana RJ, Lopez MJ, Kleiner DE, Gu J, Chalasani N. (2011). Drug-induced Liver Injury Network. Characteristics of idiosyncratic drug-induced liver injury in children: results from the DILIN prospective study. J Pediatr Gastroenterol Nutr. (Among 30 children with suspected drug induced liver injury, half [n=15] were due to antimicrobials [minocycline 4, INH 3, azithromycin 3] and the rest largely due to CNS agents and anticonvulsants; one case was attributed to amitriptyline, but no other antidepressant was listed).
Stadlmann S, Portmann S, Tschopp S, Terracciano LM. (2012). Venlafaxine-induced cholestatic hepatitis: case report and review of literature. Am J Surg Pathol. (39 year old woman developed jaundice 2.5 years after starting and 3 months after dose increase of venlafaxine [bilirubin 4.6 mg/dL, ALT 2064 U/L, Alk P 274 U/L], with a history of a similar episode when dose was increased in the past).
Coleman KA, Xavier VY, Palmer TL, Meaney JV, Radalj LM, Canny LM. (2012). An indirect comparison of the efficacy and safety of desvenlafaxine and venlafaxine using placebo as the common comparator. CNS Spectr. (Metaanalysis of controlled trials of desvenlafaxine and venlafaxine as therapy for major depression found similar rates of efficacy as measured by depression rating scales and slightly lower rates of nausea and dropout because of adverse events for desvenlafaxine).
Liebowitz MR, Tourian KA, Hwang E, Mele L, Study 3362 Investigators. (2013). A double-blind, randomized, placebo-controlled study assessing the efficacy and tolerability of desvenlafaxine 10 and 50 mg/day in adult outpatients with major depressive disorder. BMC Psychiatry. (Among 673 adults with major depression treated with desvenlafaxine [10 or 50 mg] or placebo once daily for 8 weeks, there were no differences among treatment groups in response or adverse event rates and no liver related severe adverse events and no mention of ALT elevations).
Rosenthal JZ, Boyer P, Vialet C, Hwang E, Tourian KA. (2013). Efficacy and safety of desvenlafaxine 50 mg/d for prevention of relapse in major depressive disorder: a randomized controlled trial. J Clin Psychiatry. (Among 548 adults with a history of major depression treated with desvenlafaxine [50 mg] or placebo once daily for 8 months, the probability of relapse was less with desvenlafaxine [14% vs 30%] and adverse event rates were similar; no mention of ALT elevations or hepatotoxicity).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to venlafaxine despite it being one of the 50 most prescribed drugs in Iceland).
Park SH, Ishino R. (2013). Liver injury associated with antidepressants. Curr Drug Saf. (Review of hepatotoxicity of modern antidepressants).
Voican CS, Corruble E, Naveau S, Perlemuter G. (2014). Antidepressant-induced liver injury: a review for clinicians. Am J Psychiatry. (Review of hepatotoxicity of antidepressants, mentions 9 case reports from venlafaxine with latency of 10 days to 6 months, both hepatocellular and cholestatic injury, with liver transplant in 1 and with recovery in 9).
Findling RL, Groark J, Chiles D, Ramaker S, Yang L, Tourian KA. (2014). Safety and tolerability of desvenlafaxine in children and adolescents with major depressive disorder. J Child Adolesc Psychopharmacol. (Among 40 children and adolescents with major depression enrolled in a 6 month, open label extension trial of desvenlafaxine, 21 discontinued therapy early but none because of liver disease or ALT elevations; mean levels of ALT and AST did not change).
Boyer P, Vialet C, Hwang E, Tourian KA. (2015). Efficacy of desvenlafaxine 50 mg/d versus placebo in the long-term treatment of major depressive disorder: a randomized, double-blind trial. Prim Care Companion CNS Disord. (Among 548 patients with major depression who responded to an open label course of desvenlafaxine and then were randomized to continue therapy or be withdrawn [placebo], 74% on venlafaxine maintained a remission vs 52% on placebo; adverse event rates and ALT results were not reported ).
Clayton AH, Tourian KA, Focht K, Hwang E, Cheng RF, Thase ME. (2015). Desvenlafaxine 50 and 100 mg/d versus placebo or the treatment of major depressive disorder: a phase 4, randomized controlled trial. J Clin Psychiatry. (Among 909 patients with major depression treated with desvenlafaxine [50 or 100 mg] or placebo for 8 weeks, improvements in depression rating scores were greater for desvenlafaxine while rates of adverse events were similar and there were no serious hepatic adverse events).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 20 cases [2%] were attributed to antidepressants including 9 due to SNRIs including duloxetine [n=7], nefazodone [n=1], trazodone [n=1], and 5 to SSRIs including escitalopram [n=3], fluoxetine [n=1] and sertraline [n=1], but none were attributed to venlafaxine).
Friedrich ME, Akimova E, Huf W, Konstantinidis A, Papageorgiou K, Winkler D, Toto S, et al. (2016). Drug-induced liver injury during antidepressant treatment: results of AMSP, a drug surveillance program. Int J Neuropsychopharmacol. (Among 184,234 psychiatric inpatients from 80 hospitals, 149 cases [0.08%] of drug induced liver injury were reported including 25 [0.09%] attributed to venlafaxine, most cases being asymptomatic and anicteric).
Iragavarapu C, Gupta T, Chugh SS, Aronow WS, Frishman WH. (2016). Type B lactic acidosis associated with venlafaxine overdose. Am J Ther. (55 year old man developed nausea, tachycardia and high lactate levels within hours of taking an overdose of venlafaxine [lactate 8.6 mmol/L, pH 7.39] with normal liver tests, resolving within 24 hours with hydration and medical support).
Poitras V, Visintini S. Desvenlafaxine versus venlafaxine for the treatment of adult patients with major depressive disorder: a review of the comparative clinical and cost-effectiveness [Internet]. Ottawa (ON): Canadian Agency for Drugs and Technologies in Health; 2017 Oct 25. Available from http://www.ncbi.nlm.nih.gov/books/NBK507133/ (Review of systematic reviews on the comparison of the efficacy of desvenlafaxine and venlafaxine concluded that the two agents were similar in effectiveness).
Ferrajolo C, Scavone C, Donati M, Bortolami O, Stoppa G, Motola D, Vannacci A, et al., DILI-IT Study Group. (2018). Antidepressant-induced acute liver injury: a case-control study in an Italian inpatient population. Drug Saf. (Among 179 cases of hospitalizations for unexplained acute liver injury enrolled in an Italian prospective study between 2010 and 2014, 17 had been exposed to antidepressants including citalopram [n=4], sertraline [n=3], amitriptyline [n=3] and paroxetine [n=2], but venlafaxine was not implicated in any case).
Billioti de Gage S, Collin C, Le-Tri T, Pariente A, Bégaud B, Verdoux H, Dray-Spira R, et al. (2018). Antidepressants and hepatotoxicity: A cohort study among 5 million individuals registered in the French National Health Insurance Database. CNS Drugs. (Among 5 million persons identified in a national French health insurance database who started an antidepressant between 2010 and 2015, 382 developed serious liver injury resulting in hospitalization, rates per 100,0000 persons-years being 19 for SSRIs, 22 venlafaxine, 13 duloxetine, and 33 mirtazapine).
Atkinson S, Lubaczewski S, Ramaker S, England RD, Wajsbrot DB, Abbas R, Findling RL. (2018). Desvenlafaxine versus placebo in the treatment of children and adolescents with major depressive disorder. J Child Adolesc Psychopharmacol. (Among 363 children with major depression treated with desvenlafaxine in two doses or placebo for 8 weeks, there were no changes in depression rating scores and side effect rates were similar in all groups, mean ALT, AST and Alk P levels not changing significantly).
Atkinson S, Thurman L, Ramaker S, Buckley G, Jones SR, England R, Wajsbrot D. (2019). Safety, tolerability, and efficacy of desvenlafaxine in children and adolescents with major depressive disorder: results from two open-label extension trials. CNS Spectr. (Analysis and comparison of two 6-month open-label trials of desvenlafaxine in 552 children and adolescents with major depression found no new safety signals; no discussion of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Venlafaxine: from PubMed.gov2. (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=venlafaxine+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D)) Trials on Venlafaxine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=venlafaxine)
  3 Recent References on Desvenlafaxine: from PubMed.gov4. (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=desvenlafaxine+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D)) Trials on Desvenlafaxine: from ClinicalTrials.gov (https://www.clinicaltrials.gov/ct2/results?term=desvenlafaxine)